# Glatiramer Acetate

## OVERVIEW

### Introduction

Glatiramer acetate is a mixture of synthetic polypeptides that has unique antiinflammatory and immunomodulatory activities and that is used to treat relapsing-remitting multiple sclerosis. Glatiramer therapy is associated with a low rate of transient serum enzyme elevations during therapy and has been linked to rare instances of clinically apparent liver injury with jaundice.

### Background

Glatiramer (gla tir' a mer) acetate is a mixture of synthetic polypeptides containing 4 amino acids: glutamic acid, alanine, tyrosine and lysine. The amino acid polymers have distinctive immunomodulatory activities in multiple sclerosis which are believed to be due to inhibition of binding of myelin proteins to major histocompatibility complex (MHC) molecules, which interrupts T cell activation directed at basic myelin. In several large, randomized controlled trials, glatiramer was shown to reduce relapse rates and improve neuroradiologic outcomes in adult patients with relapsing-remitting multiple sclerosis. Glatiramer was approved for use for multiple sclerosis in the United States in 1996 and is available in prefilled syringes of 20 mg and 40 mg generically and under the brand names Copaxone and Glatopa. The recommended dose is 20 mg subcutaneously once daily or 40 mg three times weekly. Common side effects are injection site reactions (pain, erythema, pruritus, induration), as well as mild and transient hypersensitivity reactions of flushing, chest tightness, dyspnea and anxiety occurring within minutes of the injection in about 10% of patients.

### Hepatotoxicity

In large randomized controlled trials of glatiramer acetate in patients with multiple sclerosis, serum ALT elevations above 3 times ULN were reported in 7% of glatiramer compared to 3% of placebo recipients. The enzyme elevations were usually transient and not associated with symptoms or jaundice, requiring drug discontinuation in less than 1% of patients. No cases of acute hepatitis or clinically apparent liver injury were reported in the preregistration trials of glatiramer. Subsequent to the approval and more wide spread use of glatiramer, however, more than a dozen instances of clinically apparent liver injury with jaundice have been reported. The onset has been within 1 to 3 months of starting therapy, and the typical presentation has been with a hepatocellular pattern of serum enzyme elevations sometimes with autoantibodies (ANA, SMA), but without hyperglobulinemia or histologic features of autoimmune hepatitis. Reported cases have been self-limited with recovery within 1 to 3 months of stopping treatment. Autoantibodies also resolve with resolution of the liver injury. Some patients have later presented with spontaneous autoimmune hepatitis, which has been described in patients with multiple sclerosis not on disease modifying agents.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which glatiramer might cause liver injury is not known, but is likely due to a triggering of an underlying predisposition to autoimmune hepatitis. The synthetic polypeptides are metabolized in multiple cells and the amino acids are probably reused in protein synthesis. Thus, the polypeptides are more likely to trigger an autoimmune reaction rather than cause direct hepatic injury or provide an immunogenic metabolic break-down product.

### Outcome and Management

While chronic therapy with glatiramer acetate can be associated with mild-to-moderate serum aminotransferase elevations, these elevations are usually transient and asymptomatic and rarely require dose interruption. Rare instances of acute liver injury with jaundice have resolved with discontinuation. Corticosteroid therapy should be considered in instances with severe or persistent liver injury, but the dose and duration of therapy should be kept to a minimum. There is little evidence for cross sensitivity to liver injury among the various disease modifying drugs for multiple sclerosis such as methyl fumarate, fingolimod, teriflunomide and interferon beta. However, in several instances, the pattern of injury is similar and autoimmunity a likely mechanism.

Drug Class: Multiple Sclerosis Agents

## CASE REPORT

### Case 1. Acute self-limited hepatitis attributed to glatiramer acetate therapy.(1)

A 31 year old woman with relapsing multiple sclerosis developed fatigue, anorexia and jaundice five weeks after starting glatiramer acetate (20 mg subcutaneously once daily). Her multiple sclerosis had been recently diagnosed and she had not received previous disease modifying therapy. She had no history of liver disease, drank alcohol sparingly and denied having risk factors for viral hepatitis. She had a melanoma removed surgically 5 years previously, but did not receive systemic chemotherapy and had no evidence of recurrence. Her only other medication was thyroxine for hypothyroidism. She had a history of depression, but was not receiving antidepressants. She had no history of drug allergies and was not taking over-the-counter or herbal medications. Examination revealed jaundice, but no other evidence for acute or chronic liver disease. Laboratory testing showed a serum bilirubin of 6.4 mg/dL, ALT 1056 U/L, AST 276 U/L, alkaline phosphatase 143 U/L and GGT 341 U/L. Values had been normal when tested before glatiramer therapy (Table). Serum albumin was 3.7 g/dL, globulins 2.9 g/dL and prothrombin time 21 seconds. Tests for hepatitis A, B and C and for EBV and CMV infections were negative. While antinuclear and liver-kidney membrane antibodies were negative, smooth muscle antibodies (SMA) were present (1:320). Ultrasonography showed increased echogenicity of the liver without evidence of biliary obstruction or masses. A liver biopsy showed acute hepatitis with bridging hepatic necrosis, which was considered more likely due to a toxic than autoimmune process. Glatiramer was stopped, and she began to improve rapidly. Two months and eight months later her symptoms had resolved, SMA was no longer positive and all liver tests were normal.

#### Key Points

Medication: | Glatiramer acetate (20 mg subcutaneously once daily)
Pattern: | Hepatocellular (R=~20)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 5 weeks
Recovery: | Within two months
Other medications: | Thyroxine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | 0 | 18 | 56 | 0.5 | Routine
5 weeks | 0 | 1056 | 143 | 6.4 | Jaundice, admission
13 weeks | 8 weeks | 40 | 79 | 1.2 | Follow-up
1 year | 8 months | Normal | Normal | Normal | SMA negative
Normal Values | | <55 | <110 | <1.2

#### Comment

A young woman with new onset multiple sclerosis developed jaundice within 5 weeks of starting subcutaneous injections of glatiramer acetate. She had no other risk factors for liver disease and laboratory testing and hepatic imaging excluded other common causes of jaundice. The disease resolved rapidly once glatiramer was stopped. This case is fairly typical of the clinically apparent acute liver injury reported with glatiramer, with onset between 1 and 3 months of starting, a hepatocellular pattern of liver injury, occasional autoantibody formation (which can also accompany multiple sclerosis), and rapid improvement upon stopping. The cause of the injury is unclear as it is unlikely that small polypeptides could be hepatotoxic. Thus, a more likely possibility is that the liver injury is due to autoimmune response induced by the therapy, perhaps as a part of the autoimmune predisposition that accompanies multiple sclerosis. The liver injury typically resolves even without immunosuppressive therapy. Glatiramer acetate therapy has been associated with activation of other autoimmune conditions during treatment including myasthenia gravis and autoimmune thyroiditis.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Glatiramer Acetate – Generic, Copaxone®, Glatopa®

DRUG CLASS

Multiple Sclerosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Glatiramer+Acetate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Glatiramer Acetate | 147245-92-9 | Protein | Not Available

## CITED REFERENCES

1. Subramaniam K, Pavli P, Llewellyn H, Chitturi S. Glatiramer acetate induced hepatotoxicity. Curr Drug Saf 2012; 7: 186-8. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/22873505).

## ANNOTATED BIBLIOGRAPHY

References updated: 20 September 2025

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 697-8. (Expert review of hepatotoxicity published in 1999; glatiramer is not discussed).
Krensky AM, Azzi JR, Hafler DA. Immunotherapy for multiple sclerosis. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 649-652. (Textbook of pharmacology and therapeutics).
De Keyser J. Autoimmunity in multiple sclerosis. Neurology 1988; 38: 371-4. (Among 828 patients with multiple sclerosis seen at a single referral center in the UK, 4.8% had a history of another autoimmune disease [most frequently hyper- or hypothyroidism, rheumatoid arthritis or diabetes] and serologic testing showed autoantibodies in 41% of 105 multiple sclerosis patients [without known autoimmune disease] compared to 23% of neurologic disease controls, most frequently ANA and parietal cell antibodies). 3347339
Johnson KP, Brooks BR, Cohen JA, Ford CC, Goldstein J, Lisak RP, Myers LW, et al. Copolymer 1 reduces relapse rate and improves disability in relapsing-remitting multiple sclerosis: results of a phase III multicenter, double-blind placebo-controlled trial. The Copolymer 1 Multiple Sclerosis Study Group. Neurology 1995; 45: 1268-76. (Among 250 patients with multiple sclerosis treated with glatiramer or placebo by daily injection for 2 years, relapse rates were 29% lower with glatiramer and side effects were similar except for injection site reactions and immediate post-injection systemic reactions [15% vs 3%]; there were no differences in laboratory test results between the two groups). 7617181
Glatiramer acetate for relapsing multiple sclerosis. Med Lett Drugs Ther 1997; 39 (1004): 61-2. (Concise review of mechanism of action, efficacy, safety and costs of glatiramer acetate for relapsing multiple sclerosis shortly after its approval in the US, mentions injection reactions [local and systemic], but that "no hematological or hepatic toxicity has been detected"). 9217693
Frese A, Bethke F, Lün P, Stöuer F. Development of myasthenia gravis in a patient with multiple sclerosis during treatment with glatiramer acetate. J Neurol 2000; 247: 713. (35 year old woman with relapsing multiple sclerosis developed ptosis due to myasthenia gravis 18 months after starting glatiramer [Anti-AChR positive], glatiramer was stopped and she was treated with thymectomy, azathioprine and corticosteroids; mentions that myasthenia has been described in patients with multiple sclerosis on no specific therapy and with interferon-beta). 11081814
Comi G, Filippi M, Wolinsky JS. European/Canadian multicenter, double-blind, randomized, placebo-controlled study of the effects of glatiramer acetate on magnetic resonance imaging--measured disease activity and burden in patients with relapsing multiple sclerosis. European/Canadian Glatiramer Acetate Study Group. Ann Neurol 2001; 49: 290-7. (Among 239 patients with multiple sclerosis who were treated with glatiramer or placebo for 9 months, relapse rates were 33% lower in the glatiramer treated patients and side effects were similar except for injection site reactions [71% vs 28%] and immediate systemic reactions [38% vs 13%]; there were no differences in laboratory results between groups). 11261502
Heesen C, Gbadamosi J, Schoser BG, Pöu D. Autoimmune hyperthyroidism in multiple sclerosis under treatment with glatiramer acetate--a case report. Eur J Neurol 2001; 8: 199. (30 year old woman with relapsing multiple sclerosis developed clinically apparent hyperthyroidism 3 years after starting glatiramer therapy; no mention of autoantibody titers or liver tests). 11285002
de Seze J, Canva-Delcambre V, Fajardy I, Delalande S, Stojkovic T, Godet E, Vermersch P. Autoimmune hepatitis and multiple sclerosis: a coincidental association? Mult Scler 2005; 11: 691-3. (Among 1800 patients with multiple sclerosis followed at regular 6 month intervals at a single French referral center, 5 [0.3%] developed a sustained increase in serum enzymes, 2 of whom had fatty liver disease and 3 autoimmune hepatitis [ANA negative] that eventually required long-term corticosteroid therapy). 16320729
Neumann H, Csepregi A, Sailer M, Malfertheiner P. Glatiramer acetate induced acute exacerbation of autoimmune hepatitis in a patient with multiple sclerosis. J Neurol 2007; 254: 816-7. (71 year old man with multiple sclerosis developed ALT elevations during interferon beta therapy and, when switched to glatiramer, developed jaundice [bilirubin 7.5 mg/dL, ALT 317 U/L, Alk P 138 U/L, ANA 1:1280], resolving within 4 weeks of stopping, but then presented one year later with spontaneous autoimmune hepatitis responding to budesonide). 17351724
von Kalckreuth V, Lohse AW, Schramm C. Unmasking autoimmune hepatitis under immunomodulatory treatment of multiple sclerosis--not only beta interferon. Am J Gastroenterol 2008; 103: 2147-8; author reply 2148. (42 year old woman with relapsing multiple sclerosis developed hepatitis and jaundice while on interferon beta, resolving upon stopping, but recurring within 2 weeks of starting glatiramer [bilirubin 14.7 mg/dL, INR 1.6], responding to corticosteroid therapy but developing ANA and SMA reactivity). 18796115
Deltenre P, Peny MO, Dufour A, Nady ME, Henrion J. Acute hepatitis induced by glatiramer acetate. BMJ Case Rep. 2009; 2009. PMID: 21686565 (52 year old woman with multiple sclerosis was found to have elevated ALT levels 3 months after starting glatiramer and one month after a 5 day course of high dose methylprednisone [bilirubin normal, ALT 8 times ULN, Alk P normal, ANA 1:320], resolving rapidly only once glatiramer was stopped).
Carter NJ, Keating GM. Glatiramer acetate: a review of its use in relapsing-remitting multiple sclerosis and in delaying the onset of clinically definite multiple sclerosis. Drugs 2010; 70: 1545-77. (Systematic review of the mechanism of action, pharmacology, efficacy and safety of glatiramer acetate in multiple sclerosis mentions that ALT elevations are less common with glatiramer than interferon beta; no mention of hepatotoxicity). 20687620
Fox RJ, Miller DH, Phillips JT, Hutchinson M, Havrdova E, Kita M, Yang M, et al.; CONFIRM Study Investigators. Placebo-controlled phase 3 study of oral BG-12 or glatiramer in multiple sclerosis. N Engl J Med 2012; 367: 1087-97. (Controlled trial of dimethyl fumarate vs glatiramer vs placebo in 1417 patients with relapsing multiple sclerosis; ALT elevations above 3 times ULN occurred in 6% of dimethyl fumarate, 7% of glatiramer and 6% of placebo recipients, but no patient developed jaundice or clinically apparent liver injury). 22992072
Arruti M, Castillo-Triviñ, de la Riva P, Martíassó, Ló de Munain A, Olascoaga J. [Autoimmune hepatitis in a patient with multiple sclerosis under treatment with glatiramer acetate]. Rev Neurol 2012; 55: 190-2. Spanish. PMID: 22825980 (46 year old woman developed fatigue 2 months after starting glatiramer acetate [bilirubin 1.8 mg/dL, ALT 579 rising to 1055 U/L, Alk P normal, INR 1.6], biopsy suggesting autoimmune hepatitis despite ANA and SMA negativity, liver tests becoming normal after corticosteroid therapy that was later switched to azathioprine alone).
Subramaniam K, Pavli P, Llewellyn H, Chitturi S. Glatiramer acetate induced hepatotoxicity. Curr Drug Saf 2012; 7: 186-8. (31 year old woman with relapsing multiple sclerosis developed jaundice 5 weeks after starting glatiramer acetate [bilirubin 6.4 mg/dL, ALT 1056 U/L, Alk P 143 U/L], resolving within 8 weeks of stopping: Case 1). 22873505
New drugs for relapsing multiple sclerosis. Med Lett Drugs Ther 2012; 54 (1403): 89-91. (Concise review of efficacy, safety and costs of new disease modifying drugs for multiple sclerosis lists side effects in a table including "transaminase elevations" for interferon beta, fingolimod and teriflunomide, and "hepatotoxicity" for natalizumab, but not for glatiramer or mitoxantrone). 23183318
Makhani N, Ngan BY, Kamath BM, Yeh EA. Glatiramer acetate-induced acute hepatotoxicity in an adolescent with MS. Neurology 2013; 81: 850-2. (15 year old girl with relapsing multiple sclerosis developed ALT elevations 6 months after starting interferon beta therapy and again 2 months after starting glatiramer [bilirubin normal, ALT 253 U/L, ANA & SMA negative], resolving within 2 months of stopping ). 23884038
Onmez A, Eminler AT, Ergenç H, Baykara M, Uslan I, Tamer A. Drug-induced liver injury by glatiramer acetate used for treatment of multiple sclerosis: a case report. J Investig Med High Impact Case Rep 2013; 1: 2324709613517493. (36 year old woman with multiple sclerosis developed jaundice a month after starting glatiramer [bilirubin 24.4 mg/dL, ALT 1475 U/L, Alk P 231 U/L, ANA negative], liver tests returning to normal within 6 weeks of stopping). 26425591
Antezana A, Herbert J, Park J, Kister I. Glatiramer acetate-induced acute hepatotoxicity in an adolescent with MS. Neurology 2014; 82: 1846-7. (28 year old woman with multiple sclerosis developed jaundice 6 months after starting glatiramer [bilirubin 8 mg/dL, ALT 1103 U/L], resolving within 1 month of stopping and not recurring on natalizumab; mentions that FDA has received 95 reports of liver injury attributed to glatiramer). 24843037
Sinagra E, Raimondo D, Cottone S, Guddo F, Gabriele Rizzo A, Amvrosiadis G, Perricone G, et al. Does glatiramer acetate provoke hepatitis in multiple sclerosis? Mult Scler Relat Disord 2014; 3: 266-8. (Two women with relapsing multiple sclerosis, ages 29 and 41 years, developed jaundice one month after starting glatiramer, having had serum enzyme elevations without jaundice on interferon beta [bilirubin 4 and 5 mg/dL, ALT 1260 and 4410 U/L, Alk P 342 and 383 U/L, ANA 1:160 and 1:320], resolving with stopping in one patient, but requiring long term corticosteroid therapy in the second). 25878015
La Gioia S, Bacis G, Sonzogni A, Frigeni B, Conti MZ, Vedovello M, Rottoli M. Glatiramer acetate-induced hepatitis in a young female patient with multiple sclerosis. Mult Scler Relat Disord 2014; 3: 732-4. (25 year old woman with relapsing multiple sclerosis developed ALT elevations 7-8 months after starting glatiramer [ALT 106 rising to 1433 U/L, bilirubin 1.5 mg/dL, Alk P 113 U/L, ANA & SMA negative], resolving within 2 months of stopping). 25891553
Pawate S, Bagnato F. Newer agents in the treatment of multiple sclerosis. Neurologist 2015; 19: 104-17. (Summary of the efficacy and safety of new drugs for multiple sclerosis mentions that fingolimod, laquinimod and teriflunomide have been associated with serum enzyme elevations during treatment, but no specifics given). 25888198
English C, Aloi JJ. New FDA-Approved Disease-Modifying Therapies for Multiple Sclerosis. Clin Ther 2015; 37: 691-715. (Systematic review of efficacy and safety of the newer disease modifying therapies of multiple sclerosis lists ALT elevations as adverse events associated with fingolimod, teriflunomide and dimethyl fumarate, but not peginterferon beta or alemtuzumab). 25846320
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 [0.8%] were attributed to interferon beta, but none were linked to glatiramer or other drugs used for multiple sclerosis). 25754159
Feinstein A, Freeman J, Lo AC. Treatment of progressive multiple sclerosis: what works, what does not, and what is needed. Lancet Neurol 2015; 14: 194-207. (Commentary on management of progressive multiple sclerosis in which most of the new, disease modifying agents have little effect, and major attention should be paid to management and relief of symptoms such as fatigue, bladder dysfunction, spasticity, pain, depression and cognitive dysfunction; no discussion of liver related adverse effects). 25772898
Fernández Fernández N, Joao Matias D, Pisabarros Blanco C, Rodríguez Martín L, Aparicio Cabezudo M, Linares Torres P, Hernando Martín M, et al. [Hepatitis induced by glatiramer acetate]. Gastroenterol Hepatol 2015; 38: 280-1. (42 year old woman with multiple sclerosis on glatiramer for 6 months was found to have ALT elevations [bilirubin 2.2 mg/dL, ALT 602 U/L, Alk P normal] which fell into the near normal range within one month of stopping, although ANA became positive [1:640]). 25042243
Almeida J, Solà-Valls N, Pose E, Blanco Y, Sepúlveda M, Llufriu S, Gines P, et al. Liver injury and glatiramer acetate, an uncommon association: case report and literature review. Ther Adv Neurol Disord 2017; 10: 367-372. (65 year old woman with multiple sclerosis developed abnormal liver tests one week after starting glatiramer acetate [bilirubin normal, ALT 481 rising to 667 U/L, Alk P normal], resolving 5 months after stopping). 29090021
Filippi M, Bar-Or A, Piehl F, Preziosa P, Solari A, Vukusic S, Rocca MA. Multiple sclerosis. Nat Rev Dis Primers. 2018;4:43. (Review of the pathogenesis, clinical features, natural history, management and therapy of multiple sclerosis). 30410033
Antonazzo IC, Poluzzi E, Forcesi E, Riise T, Bjornevik K, Baldin E, Muratori L, et al. Liver injury with drugs used for multiple sclerosis: a contemporary analysis of the FDA Adverse Event Reporting System. Mult Scler. 2019;25:1633-1640. PIMD: 30230957. (Among 4873 cases of severe liver injury attributed to agents used to treat multiple sclerosis reported to the FDA’s Adverse Event Reporting System between 2004 and 2016, the most frequently implicated agents were interferon-beta1a [n=2343], natalizumab [n=759], interferon beta1b [535], fingolimod [496], dimethyl fumarate [223], glatimer acetate [212] and teriflunomide [158].
Michels S, Zizer E, Barth TF, Wassner A, Fangerau T, Taranu D, Bachhuber F, et al. Drug-induced liver injury associated with the biosimilar glatiramer acetate (Clift®). Mult Scler Relat Disord. 2020;40:101948.. (23 year old woman with multiple sclerosis developed slight ALT elevations [55 U/L] 39 days after a second 5 day course of iv methylprednisolone and at the end of 25 day course of glatiramer with further increase in ALT levels 15 days later [bilirubin “unaltered”, ALT ~1500 U/L, GGT ~215 U/L], improving rapidly with high dose oral prednisolone). 31972518
Biolato M, Bianco A, Lucchini M, Gasbarrini A, Mirabella M, Grieco A. The disease-modifying therapies of relapsing-remitting multiple sclerosis and liver injury: a narrative review. CNS Drugs. 2021;35:861-880.. (Extensive review of the frequency and characteristics of hepatic injury associated with different disease modifying drugs for multiple sclerosis, mentions that in controlled trials, glatiramer therapy was associated with ALT elevations in 12% of patients that were above 5 times ULN in 2%, while discontinuations for liver injury were rare [less than 1%], but that since approval there have been at least 14 published cases of liver injury attributed to glatimer, but no case led to acute liver failure or had a fatal outcome). 34319570
Drugs for multiple sclerosis. Med Lett Drugs Ther. 2021;63(1620):42–8. [] (Concise review of the relative clinical efficacy, safety and costs of drugs for relapsing multiple sclerosis including parenteral agents [such as interferon-beta, glatiramer acetate, natalizumab, alemtuzumab, ocrelizumab, ofatumumab, rituximab and mitoxantrone] and the oral agents [such as the S1P receptor modulators, cladribine, fumarates, and teriflunomide], many of which are associated with serum ALT elevations and several have been reported to cause clinically apparent liver injury or reactivation of hepatitis B). 33976089
Amirkhani N, Khalaji A, Alehossein P, Safaei M, Aletaha N, Miroliaee A. Drug-induced liver injury by glatiramer acetate leading to liver transplant: A case report. JGH Open. 2023;7:591-593.. (43 year old woman with multiple sclerosis developed abdominal pain and jaundice 6 weeks after starting glatiramer [20 mg 3 times weekly] ultimately requiring liver transplantation after developing ascites and hepatic encephalopathy [bilirubin 28.6 mg/dL, ALT 71 U/L, AST 143 U/L, Alk P not given, INR 1.8], thus both methylprednisolone and glatiramer might have been responsible). 37649866
Ng HS, Zhu F, Zhao Y, Yao S, Lu X, Ekuma O, Evans C, Fisk JD, Marrie RA, Tremlett H. Adverse events associated with disease-modifying drugs for multiple sclerosis: a multiregional population-based study. Neurology. 2024;102:e208006.. (Among 35,894 people from 4 Canadian provinces with multiple sclerosis and available health data there was an increased risk for incident chronic liver disease in patients on teriflunomide and acute liver injury in those on dimethyl fumarate). 38181306
Dumitru-Martoiu MM, Petrescu S, Panea CA. Etiopathogenic and therapeutic considerations in a multiple sclerosis case with acute toxic hepatitis. Reports (MDPI). 2025;8:38.. (39 year old woman with multiple sclerosis on long-term natalizumab [7 years] and Ashwagandha for weight loss [1 month] took 4 to 5 tablets of acetaminophen [unknown dose] for 5 days for a upper respiratory infection and presented with jaundice and ecchymoses [bilirubin 7.6 mg/dL, ALT 2120 U/L, Alk P 247 U/L, R~25] with rapid recovery and normal ALT one week later suggesting that acetaminophen was the cause). 40710829
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, one case was attributed to fingolimod and one to natalizumab, but no other agents used to treat multiple sclerosis were listed: personal communication). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Glatiramer Acetate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Glatiramer+Acetate+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Glatiramer Acetate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Glatiramer+Acetate)